# Aficamten

## OVERVIEW

### Introduction

Aficamten is a small molecule inhibitor of cardiac myosin that is currently used to improve symptoms and functional capacity in patients with symptomatic obstructive hypertrophic cardiomyopathy. Aficamten is associated with a low rate of serum aminotransferase elevations during therapy but has not been implicated in cases of clinically apparent liver injury.

### Background

Aficamten (a fi cam’ ten) is a small molecule inhibitor of cardiac myosin that is used to reduce symptoms and increase functional capacity in patients with symptomatic obstructive hypertrophic cardiomyopathy. Hypertrophic cardiomyopathy is a genetic disease of the heart characterized by excessive myocardial contractility that leads to thickening of the cardiac ventricular walls, which can cause obstruction of blood outflow and progressive heart failure. Aficamten is a small molecule inhibitor of myosin that reduces excessive actin–myosin cross-bridge formation and limits abnormally strong and prolonged contractions. In animal models of hypertrophic cardiomyopathy, aficamten led to a reduced cardiac contractility and decrease in ventricular wall thickness. In clinical trials in adult patients with symptomatic obstructive hypertrophic cardiomyopathy, aficamten therapy led to a decrease in ventricular outflow tract obstruction, increase in peak oxygen consumption, and improvement in symptoms and functional capacity in comparison to therapy with placebo. In 2025, aficamten was given approval in the United States for use in adults with symptomatic obstructive hypertrophic cardiomyopathy. Aficamten is available in tablets of 5, 10, 15, and 20 mg under the brand name Myqorzo. The recommended starting dose is 5 mg once daily with subsequent increases by 5 mg daily every 2 to 8 weeks based upon effectiveness and tolerability. Use of the drug requires careful dose titration and echocardiographic monitoring. Common side effects include dizziness, syncope, and dyspnea, and less commonly headache, back pain, arthralgias, fever and cough. Severe adverse events can include heart failure, worsening of cardiac ejection fraction, and atrial fibrillation, because of which aficamten is available only as a part of a Risk Evaluation and Mitigation Strategy (REMS) that requires training, patient warning, and regular monitoring by echocardiograms. Based upon animal studies, aficamten has the potential of embryo-fetal toxicity, and women of child-bearing potential should practice an effective means of birth control.

### Hepatotoxicity

Liver test abnormalities are infrequent in patients treated with myosin inhibitors. In publications of placebo-controlled trials of aficamten, results of serum aminotransferases, alkaline phosphatase, and bilirubin levels were usually not mentioned. However, none of the studies listed serious hepatic adverse events and there were no deaths from liver failure. The FDA’s review of the pre-registration data on safety and efficacy of aficamten mentions that ALT elevations above 3 times the ULN occurred in 2.1% of patients receiving aficamten but in none of the controls. Nevertheless, there were no instances of clinically apparent liver injury with symptoms or jaundice. Clinical experience with aficamten therapy has been limited, but ongoing trials have supported its hepatic safety.

Likelihood score: E (unlikely cause of clinically apparent liver injury). Clinical experience is limited, however.

### Mechanism of Injury

The mechanism by which aficamten might cause serum aminotransferase elevations is not known. Aficamten is metabolized in the liver, largely by CYP 2C19 and to a lesser degree by CYP 3A4, and it is susceptible to drug-drug interactions - strong inhibitors of these CYPs (which raise drug levels) can increase adverse side effects, and moderate to strong inducers of these enzymes (which lower drug levels) may cause reduction of efficacy and need for higher daily doses.

### Outcome and Management

Aficamten therapy has not been implicated in causing liver test abnormalities or clinically apparent liver injury. However, the de novo appearance and persistent ALT or AST elevations above 3 times the upper limit of the normal range (ULN) should lead to dose adjustment or discontinuation until the cause of the abnormalities has been delineated. Any ALT elevation above 10 times the ULN or ALT elevations with symptoms or jaundice should lead to immediate discontinuation. There is no information on possible cross-sensitivity to liver damage with other myosin inhibitors such as mavacamten.

Drug Class: Cardiovascular Agents, Drugs for hypertrophic cardiomyopathy

Other Drugs in the Subclass: Cardiac myosin inhibitors: Mavacamten

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Aficamten – Myqorzo®

DRUG CLASS

Cardiovascular Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=fd778507-1274-4d1a-a659-5431d55c543a)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Aficamten | 2364554-48-1 | C18H19N5O2

## ANNOTATED BIBLIOGRAPHY

References updated: January 10, 2026

Abbreviations: ULN, upper limit of the normal range.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity of published in 1999; before the availability of cardiac myosin inhibitors).
Eschenhagen T. Therapy of heart failure. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 527-546. (Textbook of pharmacology and therapeutics, no mention of cardiac myosin inhibitors).
FDA: 2025. Integrated review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2026/219083Orig1s000TOC.html (FDA website with product label and integrated review of the safety and efficacy of aficamten provided by the drug sponsor in support of its approval for therapy of hypertrophic cardiomyopathy in the United States, mentions that in a registration-controlled trial, ALT elevations above 3 times ULN occurred in 3 patients [2.1%] on aficamten vs none on placebo. The elevations were resolved spontaneous and were not associated with symptoms or jaundice. In the registration analysis of safety there were no instances of clinically apparent liver injury).
Chuang C, Collibee S, Ashcraft L, Wang W, Vander Wal M, Wang X, Hwee DT, et al. Discovery of aficamten (CK-274), a next-generation cardiac myosin inhibitor for the treatment of hypertrophic cardiomyopathy. J Med Chem. 2021;64:14142-14152.. (Description of the design and development of aficamten as a specific inhibitor of cardiac vs smooth muscle myosin, with pharmacokinetics allowing for once a day dosing and rapid achievement of steady state kinetics, and without major effects on cytochrome P450 [CYP] activities). 34606259
Maron MS, Masri A, Nassif ME, Barriales-Villa R, Arad M, Cardim N, Choudhury L, et al.; SEQUOIA-HCM Investigators. Aficamten for symptomatic obstructive hypertrophic cardiomyopathy. N Engl J Med. 2024;390:1849-1861.. (Among 282 adults with symptomatic obstructive hypertrophic cardiomyopathy treated with aficamten [5 mg adjusting to a peak of 20 mg] vs placebo daily for 24 weeks, therapy was associated with improvements in peak oxygen uptake [+1.8 vs 0.0 mL/kg/min] and symptom scales while adverse event rates were similar [overall 74% vs 71%, serious 5.6% vs 9.3%]; no mention of ALT elevations or hepatic adverse events). 38739079
Davis BJ, Volk H, Nguyen O, Kamna D, Chen H, Barriales-Villa R, Garcia-Pavia P, Olivotto I, Owens AT, Coats CJ, Abraham TP, Solomon SD, Maron MS, Masri A. Safety and efficacy of mavacamten and aficamten in patients with hypertrophic cardiomyopathy. J Am Heart Assoc. 2025;14:e038758.. (Analysis of 10 clinical trials of mavacamten and aficamten in adults with hypertrophic cardiomyopathy, both showed benefit in reducing left ventricular outflow tract obstruction, symptom burden, and exercise parameters and both were “generally well tolerated” with major severe adverse events being heart failure, worsening of left ventricular ejection fraction, and atrial fibrillation; no mention of ALT elevations or hepatotoxicity). 40055855
Garcia-Pavia P, Maron MS, Masri A, Merkely B, Nassif ME, Peña-Peña ML, Barriales-Villa R, et al.; MAPLE-HCM Investigators. Aficamten or metoprolol monotherapy for obstructive hypertrophic cardiomyopathy. N Engl J Med. 2025;393:949-960.. (Among 175 patients with symptomatic obstructive hypertrophic cardiomyopathy treated with aficamten [5 increasing to 15-20 mg] or metoprolol [50 to 200 mg] daily for 24 weeks, aficamten treatment was associated with a greater increase in peak oxygen uptake, greater decrease in left ventricular outflow obstruction, and more improved cardiovascular status than treatment with metoprolol, while adverse event rates were similar [overall 74% vs 76%, serious 8% vs 7%]; no mention of ALT elevations or hepatotoxicity). 40888697

## OTHER REFERENCE LINKS

1. Recent References on Aficamten: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(aficamten)%20AND%20Human%5bMesh%5d%20AND%20(jaundice%20OR%20bile%20duct%20diseases%20OR%20liver%20OR%20liver%20diseases%20OR%20hepatitis,%20toxic%5bMesh%5d)%20AND%20(%222009/1/1%22%5bEDat%5d:%222999/12/31%22%5bEDat%5d))

2. Trials on Aficamten: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Aficamten)